# Rivaroxaban

## OVERVIEW

### Introduction

Rivaroxaban is an oral anticoagulant and direct factor Xa inhibitor which is used in the prevention of stroke and venous embolism in patients with chronic atrial fibrillation, as well as treatment and prevention of deep venous thromboses and pulmonary embolism. Rivaroxaban has been associated with a low rate of serum enzyme elevations during treatment and with rare instances of clinically apparent liver injury with jaundice.

### Background

Rivaroxaban (riv" a rox' a ban) is a selective inhibitor of factor Xa, the rate controlling last step in the generation of thrombin, the final intermediate in blood coagulation. Inhibiting thrombin prevents the conversion of fibrinogen to fibrin and subsequent cross linking of fibrin monomers, platelet activation and amplification of coagulation. Rivaroxaban has been shown to be as effective as warfarin in preventing stroke and systemic embolization in patients with atrial fibrillation, and to decrease the risk of deep vein thrombosis and pulmonary embolism in patients undergoing surgery. Rivaroxaban is orally available and provides a reliable anticoagulant effect for which monitoring of INR is not needed. Rivaroxaban was approved for use in the United States in 2011, the first oral factor Xa inhibitor to become available. Current indications are for prevention of stroke and embolism in patients with chronic atrial fibrillation not related to valvular heart disease, as well as prevention and treatment of deep vein thrombosis and pulmonary embolism in patients at high risk. Long term therapy in low doses given twice daily in combination with aspirin has been shown to decrease major cardiovascular events and death in patients with coronary or peripheral artery disease. Rivaroxaban is available in tablets of 2.5, 10, 15 and 20 mg generically and under the brand name Xarelto. The recommended dose in adults is 10 to 20 mg daily or 2.5 mg twice daily depending upon indication and renal function. Rivaroxaban, like other anticoagulants, is associated with an increased risk of adverse bleeding events (5% to 6%) which are considered “major” in ~1%. These bleeding adverse events, however, are no more frequent than with low molecular weight heparins or warfarin. Side effects not directly attributable to the anticoagulant activity of rivaroxaban are not common, but can include nausea, abdominal discomfort, back pain, anorexia, fever, and skin rash. Severe adverse events include major bleeding episodes, epidural or spinal hematoma, and increase in risk of thrombotic events with premature discontinuation.

### Hepatotoxicity

Chronic therapy with rivaroxaban is associated with moderate ALT elevations (greater than 3 times the upper limit of normal) in 1.5% to 3% of patients, an overall rate which is slightly lower than with low molecular weight heparins and similar to the rates with warfarin. During the large, prelicensure clinical trials of rivaroxaban, several instances of ALT elevations with jaundice occurred, but few details were provided and it was not clear whether the liver injury was clinically apparent. The cases were evidently mild and self-limited, resolving completely once therapy was stopped. Since its licensure and more wide scale use, rivaroxaban has been linked to many instances of acute liver injury with jaundice. The clinical features of these cases varied widely. Most cases had an onset within 1 to 8 weeks of starting rivaroxaban and presented with jaundice, fatigue and a hepatocellular pattern of serum enzyme elevations. In some individuals, a cholestatic or mixed pattern was found. Immunoallergic features and autoimmune markers were atypical but at least one case occurred with skin rash and fever suggestive of DRESS syndrome. One case of acute hepatic necrosis and death attributed to rivaroxaban has been reported, but ischemic hepatitis due to severe heart failure was a more likely cause of the acute liver failure. All other reported cases of rivaroxaban induced liver injury recovered upon stopping rivaroxaban, usually quite promptly, within 2 to 4 weeks. In large health care databases, hospitalization for acute liver injury arises in approximately 1 in 2,200 cases, but whether all cases in these databases represent liver injury from rivaroxaban is uncertain.

Likelihood score: A (well established cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of liver injury during rivaroxaban therapy is unknown, but is likely to be idiosyncratic and perhaps immunologic. Rivaroxaban is metabolized in the liver largely by CYP 3A4 and is susceptible to drug-drug interactions; inhibitors of CYP 3A4 (such as clarithromycin and itraconazole) can lead to increased levels, while inducers of CYP 3A4 (such as rifampin and phenytoin) can cause decreased and potential subtherapeutic drug levels.

### Outcome and Management

Liver injury attributed to rivaroxaban varies from mild serum ALT elevations to liver injury with jaundice, but is usually mild to moderate in severity and self-limited, resolving within a few weeks of stopping. Convincing examples of acute liver failure, chronic hepatitis or vanishing bile duct syndrome due to rivaroxaban have not been reported in the published literature. Recurrence of liver injury with rechallenge has not been described, but should be expected to occur. There is no evidence or reason to suspect that there is cross sensitivity to hepatic injury among the different anticoagulants even with the other direct factor X inhibitors such as apixaban and edoxaban which appear to have a lower rate of hepatotoxicity.

Drug Class: Antithrombotic Agents, Anticoagulants

Other Drugs in the Subclass, Anticoagulants, Factor Xa Antagonists: Apixaban, Betrixaban, Edoxaban, Fondaparinux

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Rivaroxaban – Xarelto®

DRUG CLASS

Antithrombotic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Rivaroxaban)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Rivaroxaban | 366789-02-8 | C19-H18-Cl-N3-O5-S

## ANNOTATED BIBLIOGRAPHY

References updated: 16 February 2023

Zimmerman HJ. Drugs used in cardiovascular disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 639-41. (Expert review of hepatotoxicity published in 1999 does not mention rivaroxaban).
De Marzio DH, Navarro VJ. Antiplatelet agents. Hepatotoxicity of cardiovascular and antidiabetic drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 527-8. (Review of hepatotoxicity of cardiovascular drugs does not discuss the anticoagulants).
Weitz JI. Blood coagulation and anticoagulant, fibrinolytic, and antiplatelet drugs. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 849-76. (Textbook of pharmacology and therapeutics).
Eriksson BI, Borris LC, Friedman RJ, Haas S, Huisman MV, Kakkar AK, Bandel TJ, et al., RECORD1 Study Group. (2008). Rivaroxaban versus enoxaparin for thromboprophylaxis after hip arthroplasty. N Engl J Med. (Among 4541 patients undergoing hip replacement surgery who were treated with oral rivaroxaban or enoxaparin for at least 1 month, combined endpoints of death or thromboembolism were less with rivaroxaban [1.1% vs 3.7%], but rates of bleeding were similar; ALT elevations occurred in 2.0% vs 2.7% of patients and one patient on rivaroxaban had elevations in both ALT and bilirubin, which resolved even with continued administration).
Lassen MR, Ageno W, Borris LC, Lieberman JR, Rosencher N, Bandel TJ, Misselwitz F, et al. (2008). RECORD3 Investigators. Rivaroxaban versus enoxaparin for thromboprophylaxis after total knee arthroplasty. N Engl J Med. (Among 2531 patients undergoing hip replacement surgery who were treated with rivaroxaban or enoxaparin, thromboembolic events and death were less common with rivaroxaban [1.0% vs 2.4%], while rates of major bleeding were similar [0.6% vs 0.5%]; ALT elevations above 3 times ULN occurred in 1.7% of both groups).
Borris LC. (2008). New compounds in the management of venous thromboembolism after orthopedic surgery: focus on rivaroxaban. Vasc Health Risk Manag. (Short review of pharmacology, efficacy and safety of rivaroxaban).
Gulseth MP, Michaud J, Nutescu EA. (2008). Rivaroxaban: an oral direct inhibitor of factor Xa. Am J Health Syst Pharm. (Review of mechanism of action, pharmacology, efficacy and safety of rivaroxaban; in large clinical trials, ALT elevations occurred in 1.9-6% of rivaroxaban vs 7.7-21.6% of enoxaparin treated subjects, and no patient developed clinically apparent liver injury clearly attributable to rivaroxaban).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, none were attributed to anticoagulants).
Turpie AG, Lassen MR, Davidson BL, Bauer KA, Gent M, Kwong LM, Cushner FD, et al. (2009). RECORD4 Investigators. Rivaroxaban versus enoxaparin for thromboprophylaxis after total knee arthroplasty (RECORD4): a randomised trial. Lancet. (Among 3148 patients undergoing knee replacement surgery who were treated with rivaroxaban or enoxaparin, thromboembolic events were less with rivaroxaban, with no increase in rates of bleeding; ALT levels above 3 times ULN occurred in 1.3% vs 2.6% of patients, and only one patient on rivaroxaban but 3 on enoxaparin developed concurrent elevations in ALT and bilirubin).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were due to anticoagulants).
(2011). Rivaroxaban (Xarelto)--a new oral anticoagulant. Med Lett Drugs Ther. (Concise review of efficacy and safety of rivaroxaban shortly after its approval for use to prevent deep vein thrombosis after hip replacement surgery discusses bleeding as an adverse event, but not ALT elevations or hepatotoxicity).
Watkins PB, Desai M, Berkowitz SD, Peters G, Horsmans Y, Larrey D, Maddrey W. (2011). Evaluation of drug-induced serious hepatotoxicity (eDISH): application of this data organization approach to phase III clinical trials of rivaroxaban after total hip or knee replacement surgery. Drug Saf. (Analysis of 4 controlled trials of rivaroxaban vs enoxaparin found ALT elevations above 3 times ULN in 2.3% vs 3.6% of patients, but combined ALT and bilirubin elevations [above 2.5 mg/dL] occurred equally in both groups [10 patients each: 0.16%]).
Turpie AG, Lassen MR, Eriksson BI, Gent M, Berkowitz SD, Misselwitz F, Bandel TJ, et al. (2011). Rivaroxaban for the prevention of venous thromboembolism after hip or knee arthroplasty. Pooled analysis of four studies. Thromb Haemost. (In a pooled analysis of 12,729 patients undergoing knee or hip replacement surgery who were treated with rivaroxaban or enoxaparin in 4 controlled trials, venous thromboembolism or death occurred in 0.5% vs 1.0% of patients by day 12; ALT elevations above 3 times ULN occurred in 2.5% vs 3.7%, and combined ALT and bilirubin elevations in 0.1% in both groups).
EINSTEIN–PE Investigators. (2012). Oral rivaroxaban for the treatment of symptomatic pulmonary embolism. N Engl J Med. (Among 4832 patients with symptomatic pulmonary embolism treated with rivaroxaban or enoxaparin/warfarin, rates of recurrence of venous thromboses and bleeding episodes were similar in the two groups, while ALT elevations above 3 times ULN occurred in 1.1% vs 2.2%, and combined ALT and bilirubin elevations occurred in 0.2% of both groups [5 and 4 patients]).
Caldeira D, Barra M, Santos AT, de Abreu D, Pinto FJ, Ferreira JJ, Costa J. (2014). Risk of drug-induced liver injury with the new oral anticoagulants: systematic review and meta-analysis. Heart. (Systematic review of 29 controlled trials of oral anticoagulants in 152,116 patients focusing on risk of drug induced liver injury [including 8 trials with 19,364 patients on rivaroxaban] found no increase in rate of serum ALT or AST elevations above 3 times ULN [1-2%], or combined enzyme and bilirubin elevations above 2 times ULN [~0.2%] with rivaroxaban vs standard therapy).
Russmann S, Niedrig DF, Budmiger M, Schmidt C, Stieger B, Hürlimann S, Kullak-Ublick GA. (2014). Rivaroxaban postmarketing risk of liver injury. J Hepatol. (Analysis of 14 cases of liver injury attributed to rivaroxaban reported to a Swiss pharmacovigilance registry; 5 men and 9 women, ages 41 to 91 years, onset after 3-62 days, given for atrial fibrillation [n=4] or orthopedic surgery [n=10], 11 with jaundice, ALT 2.5-53.7 times ULN, Alk P <1 to 7.8 times ULN, half of cases hepatocellular, none fatal; two cases presented in detail both developed cholestatic hepatitis within 2-3 weeks of surgery during which they also received cefazolin).
Moore N, Blin P, Gulmez SE. (2014). New oral anticoagulants (NOAC) and liver injury. J Hepatol. (Editorial in response to Russmann [2014] stressing the rarity of liver injury due to rivaroxaban and its generally benign outcome).
(2014). New oral anticoagulants for acute venous thromboembolism. Med Lett Drugs Ther. (Brief comparison of warfarin, rivaroxaban, apixaban and dabigatran as anticoagulants for treatment of venous thromboembolism, all of which have similar efficacy, warfarin requiring regular monitoring of INR whereas the others not).
Liakoni E, Rätz Bravo AE, Terracciano L, Heim M, Krähenbühl S. (2014). Symptomatic hepatocellular liver injury with hyperbilirubinemia in two patients treated with rivaroxaban. JAMA Intern Med. (52 year old man developed jaundice 2 months after starting rivaroxaban [bilirubin 18.7 mg/dL, ALT 1740 U/L, Alk P 136 U/L], recovering within 2 weeks of stopping; 73 year old woman developed jaundice and pruritus 1 month after starting rivaroxaban [bilirubin 7.5 mg/dL, ALT 334 U/L, Alk P 363 U/L], resolving within 2 weeks of stopping).
Lambert A, Cordeanu M, Gaertner S, Nouri S, Alt M, Stephan D. (2015). Rivaroxaban-induced liver injury: Results from a venous thromboembolism registry. Int J Cardiol. (Among 120 patients wtih venous thromboembolism treated with rivaroxaban at a single French referral center, 5 developed evidence of liver injury arising within 2 to 3 days of starting; all were anicteric, 4 had serum ALT elevations [2.4-12.3 times ULN] alone, 1 with Alk P increases [4.3 times ULN], 1 mildly symptomatic, and all recovered promptly upon stopping rivaroxaban).
Raschi E, Poluzzi E, Koci A, Salvo F, Pariente A, Biselli M, Moretti U, et al. (2015). Liver injury with novel oral anticoagulants: assessing post-marketing reports in the US Food and Drug Administration adverse event reporting system. Br J Clin Pharmacol. (Analysis of 17,097 reports to FDA on adverse events associated with newer oral anticoagulants identified 146 liver related events attributed to rivaroxaban [3.7% of total reports] with 25 resulting in acute liver failure, and 222 to dabigatran [1.7% of total] with 41 resulting in acute liver failure; case-by-case analysis was difficult "it should be acknowledged that this clinical event may not be necessarily related to the drug").
Barrett P, Vuppalanchi R, Masuoka H, Chalasani N. (2015). Severe drug-induced skin and liver injury from rivaroxaban. Dig Dis Sci. (77 year old man with retinal thrombosis developed fever, fatigue and arthralgias 6 weeks after starting rivaroxaban with subsequent skin rash, mild eosinophilia, and jaundice [peak bilirubin ~4.1 mg/dL, ALT ~400 U/L, Alk P ~650 U/L], resolving within 4 weeks of stopping).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients With drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 patients with clinically apparent drug induced liver injury enrolled in a US prospective study over an 8 year period, 2 were attributed to anticoagulants including 1 to prasugrel [platelet inhibitor] and one to dalteparin [low molecular weight heparin], but none to rivaroxaban).
Anastasia EJ, Rosenstein RS, Bergsman JA, Parra D. (2015). Use of apixaban after development of suspected rivaroxaban-induced hepatic steatosis; a case report. Blood Coagul Fibrinolysis. (67 year old man developed ALT elevations 6 months after starting rivaroxaban [peak ALT 391 U/L, Alk P 120 U/L, bilirubin 1.3 mg/dL], which fell into the normal range within 2 months of switching to apixaban; ultrasound suggested fatty liver which also resolved with stopping).
Baig M, Wool KJ, Halanych JH, Sarmad RA. (2015). Acute liver failure after initiation of rivaroxaban: a case report and review of the literature. N Am J Med Sci. (89 year old woman with severe heart failure developed acute hepatic necrosis and rapidly fatal liver failure 1 week after starting rivaroxaban [initial bilirubin 2.5 mg/dL, ALT 3011 U/L, AST 5318 U/L, Alk P 250 U/L, INR 8.5]; perhaps more likely due to ischemic hepatitis than rivaroxaban).
Liakoni E, Rätz Bravo AE, Krähenbühl S. (2015). Hepatotoxicity of new oral anticoagulants (NOACs). Drug Saf. (Systematic review of evidence of hepatotoxicity of new oral anticoagulants including rivaroxaban, apixaban, edoxaban and dabigatran found 22 cases of liver injury due to rivaroxaban, 2 dabigatran, 2 apixaban, but none to edoxaban).
Aslan AN, Sari C, Baştuğ S, Sari SÖ, Akçay M, Durmaz T, Bozkurt E. (2016). Severe jaundice due to intrahepatic cholestasis after initiating anticoagulation with rivaroxaban. Blood Coagul Fibrinolysis. (71 year old man developed jaundice one month after starting rivaroxaban [bilirubin 3.5 rising to 13.2 mg/dL, ALT 141 U/L, Alk P 257 U/L], improving once rivaroxaban was stopped with normal values one month later).
Alonso A, MacLehose RF, Chen LY, Bengtson LG, Chamberlain AM, Norby FL, Lutsey PL. (2017). Prospective study of oral anticoagulants and risk of liver injury in patients with atrial fibrillation. Heart. (Analysis of a database on more than 1 million patients with nonvalvular atrial fibrillation on oral anticoagulants identified 960 hospitalizations with liver injury, rates being highest for warfarin, intermediate for rivaroxaban, and lowest for apixaban and dabigatran).
Glenn K, Chen P, Musleh M, Pallivi R, Grilliot M. (2017). A rare case of rivaroxaban causing delayed symptomatic hepatocellular iInjury and hyperbilirubinemia. Case Rep Gastrointest Med. (74 year old woman developed jaundice 1 month after knee arthroplasty and 14 day course of rivaroxaban [bilirubin 7.5 mg/dL, ALT 506 U/L, Alk P 332 U/L] with complete resolution in follow up one year later; no mention of antibiotic administration during surgery).
Christopoulou EC, Filippatos TD, Elisaf MS. (2017). Non-hemorrhage-related adverse effects of rivaroxaban. Arch Med Sci Atheroscler Dis. (Review of non-hematologic adverse events from rivaroxaban including hepatobiliary effects with summaries of 28 cases in the literature).
Licata A, Puccia F, Lombardo V, Serruto A, Minissale MG, Morreale I, Giannitrapani L, Soresi M, Montalto G, Almasio PL. (2018). Rivaroxaban-induced hepatotoxicity: review of the literature and report of new cases. Eur J Gastroenterol Hepatol. (Review of 26 cases of suspected rivaroxaban induced liver injury from the literature and description of 2 new cases of elderly patients developing hepatocellular injury 7-8 weeks after starting rivaroxaban [bilirubin 21.8 mg/dL and not given, ALT 35 and 9 times ULN, Alk P 2 times and within ULN], both resolving rapidly within a month of stopping).
Verheyen E, Kileci JA, Mathew JP. (2019). Single-dose rivaroxaban-induced acute liver injury. Am J Ther. (87 year old man with sepsis, atrial fibrillation, and respiratory failure developed marked elevations in serum aminotransferase levels within hours of receiving a single dose of rivaroxaban [peak values on day 2: bilirubin 2.1 mg/dL, ALT 3963 U/L, AST 9549 U/L, Alk P 122 U/L, creatinine 2.8 mg/dL], with rapid recovery; the injury most likely due to ischemic hepatitis).
Björnsson HK, Gudmundsson DO, Björnsson ES. (2020). Liver injury caused by oral anticoagulants: A population-based retrospective cohort study. Liver Int. (Search of Icelandic National Prescription Databases and Health Records identified 3 cases of clinically apparent, acute liver injury in 3 of 3446 [0.1%] patients taking rivaroxaban, but in none of 9101 taking warfarin, 1903 apixaban, 1335 dabigatran or 34 taking edoxaban).
Zhao J, Blais JE, Chui CSL, Suh IH, Chen EYH, Seto WK, Mok MT, et al. (2020). Association between nonvitamin K antagonist oral anticoagulants or warfarin and liver injury: a cohort study. Am J Gastroenterol. (Among 13,698 patients with atrial fibrillation started on anticoagulant therapy and followed in the Hong Kong Clinical Database and Reporting system between 2010 and 2016, 513 [2.8%] developed evidence of liver injury and propensity matching indicated that liver injury was less frequent [2.1% vs 3.4%], although more severe with oral anticoagulants than with warfarin).
Maura G, Bardou M, Billionnet C, Weill A, Drouin J, Neumann A. (2020). Oral anticoagulants and risk of acute liver injury in patients with nonvalvular atrial fibrillation: a propensity-weighted nationwide cohort study. Sci Rep. (Among 434,015 patients with atrial fibrillation started on anticoagulant therapy and followed in the French National Healthcare Database, 218 [0.6%] were subsequently hospitalized for acute liver injury, the rates being similar for those on dabigatran [26 of 51,737 patients], apixaban [29 of 62,503 patients] and rivaroxaban [46 of 99,408 patients]).
Zhou J, Leung KSK, Kong D, Lee S, Liu T, Wai AKC, Chang C, et al. (2021). Low rates of liver injury in edoxaban users: Evidence from a territory-wide observational cohort study. Clin Cardiol. (Among 1213 patients with atrial fibrillation started on edoxaban between 2016 and 2020 and followed in the Hong Kong Clinical Database and Reporting System, 19 [1.5%] developed evidence of liver injury, a rate below that previously reported for warfarin [3.7%], apixaban [2.5%], and rivaroxaban [2.1%]).
Rao V, Munasinghe A. (2021). Acute liver failure after changing oral anticoagulant from apixaban to rivaroxaban. BMJ Case Rep. (88 year old man with atrial fibrillation was switched from apixaban to rivaroxaban [15 mg daily] after experiencing a transient ischemic attack and developed jaundice 2 weeks later [bilirubin 11.2 mg/dL, ALT 1940 U/L, Alk P 360 U/L] but no hepatic encephalopathy, recovering rapidly upon switching to warfarin).
Marrinan A, Shackleton L, Kelly C, Lavin M, Glavey S, Murphy P, Quinn J. (2021). Liver injury during rivaroxaban treatment in a patient with AL amyloidosis. Eur J Clin Pharmacol. (57 year old man with amyloidosis developed asymptomatic elevations in serum enzymes 5 months after starting rivaroxaban for a pulmonary embolus [bilirubin 0.6 mg/dL, ALT 544 rising to 806 U/L while continuing rivaroxaban, Alk P 142 U/L], resolving within 2 months of switching to tinzaparin).
Ma J, Chalasani NP, Schwantes-An L, Björnsson ES. (2023). Review article: the safety of anticoagulants and antiplatelet agents in patients with cirrhosis. Aliment Pharmacol Ther. (Review of the safety of anticoagulant use in patients with cirrhosis mentions that drug induced liver injury is uncommon in patients with preexisting cirrhosis, at least in those with compensated [Child’s Class A] or mildly compensated [Child’s Class B] cirrhosis).

## OTHER REFERENCE LINKS

1 Recent References on Rivaroxaban: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Rivaroxaban/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Rivaroxaban: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Rivaroxaban)